# Phosphodiesterase Type 5 (PDE5) Inhibitors

## OVERVIEW

The phosphodiesterase type 5 (PDE5) inhibitors cause vasodilation in the penis and lung by blocking the breakdown of cyclic guanosine monophosphate (cGMP) which results in prolongation of the action of mediators of vasodilation including nitric oxide (NO). The type-5 phosphodiesterases are isoforms of this enzyme that are found primarily in the corpus cavernosum of penis and vasculature of the lung. For these reasons, the two major actions of the PDE5 inhibitors are to prolong penile erection and decrease pulmonary vascular pressure. They have little effect on the systemic vasculature.

Four PDE5 inhibitors are currently approved and in use for treatment of erectile dysfunction including sildenafil (Viagra: 1998), tadalafil (Cialis: 2003), vardenafil (Levitra: 2003) and avanafil (Stendra: 2012), all of which are recommended to be taken orally one-half to 4 hours before sexual intercourse. Typically, no more than once daily use is recommended. The PDE5 inhibitors are not approved for use in women. Sildenafil is approved for use in pulmonary hypertension where two to three times daily chronic dosing is used. Its safety and efficacy are still under experimental evaluation, particularly in patients with end stage liver disease (hepato-pulmonary syndrome) and in patients with sickle cell anemia with pulmonary hypertension.

Rare single case reports of acute liver injury have been reported with use of PDE5 inhibitors, mostly with sildenafil, most likely becausethe others have been available for a shorter time and are less commonly used. The four agents share a similar mechanism of action, but have structural differences, and it is not clear whether liver injury is a class effect or specific to sildenafil. Chronic sildenafil use has not been associated with serum aminotransferase elevations.

The following links are to individual drug records. References to hepatotoxicity and safety of the PDE5 inhibitors are given together after this Overview section.

- Avanafil
- Sildenafil
- Tadalafil
- Vardenafil

## ANNOTATED BIBLIOGRAPHY

References updated: 02 August 2017

Abbreviations: PDE5, phosphodiesterase type 5

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, p. 717. (Textbook of hepatotoxicity published in 1999, before the availability of PDE5 inhibitors).
Michel T, Hoffman BB. Therapy of myocardial ischemia and hypertension. In, Brunton LL, Lazo JS, Parker KL, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 745-88. (Textbook of pharmacology and therapeutics; use of PDE5 inhibitors with nitrates can cause severe hypotension; PDE5 inhibitors in current use are metabolized by CYP3A4 and drug-drug interactions may also complicate their use).
Goldstein I, Lue TF, Padma-Nathan H, Rosen RC, Steers WD, Wicker PA. Oral sildenafil in the treatment of erectile dysfunction. Sildenafil Study Group. N Engl J Med 1998; 338: 1397-404. (Randomized controlled trial of sildenafil vs placebo in 532 men for 24 weeks; “Laboratory test results indicated no evidence of sildenafil-induced abnormalities”). 9580646
Rendell MS, Rajfer J, Wicker PA, Smith MD. Sildenafil for treatment of erectile dysfunction in men with diabetes: a randomized controlled trial. Sildenafil Diabetes Study Group. JAMA 1999; 281: 421-6. (Randomized controlled trial of sildenafil vs placebo in 268 men; side effects included headache, dyspepsia, flushing, rhinitis and visual disturbance; “There were no laboratory test abnormalities attributable to sildenafil use”). 9952201
Christiansen E, Guirguis WR, Cox D, Osterloh IH; Sildenafil Multicentre Study Group. Long-term efficacy and safety of oral Viagra (sildenafil citrate) in men with erectile dysfunction and the effect of randomised treatment withdrawal. Int J Impot Res 2000; 12: 177-82. (Study of 233 men treated with sildenafil for 16 weeks, followed by 8 weeks withdrawal and then open label study; flushing in 7%, headache 6%, dyspepsia 5%; no reports of jaundice or hepatitis, but no ALT monitoring). 11045912
Chen KK, Hsieh JT, Huang ST, Jiaan DB, Lin JS, Wang CJ; ASSESS-3 Study Group. ASSESS-3: a randomised, double-blind, flexible-dose clinical trial of the efficacy and safety of oral sildenafil in the treatment of men with erectile dysfunction in Taiwan. Int J Impot Res 2001; 13: 221-9. (Randomized controlled trial of sildenafil vs placebo in 236 patients; no mention of ALT elevations or liver injury). 11494079
Brock GB, McMahon CG, Chen KK, Costigan T, Shen W, Watkins V, Anglin G, Whitaker S. Efficacy and safety of tadalafil for the treatment of erectile dysfunction: results of integrated analyses. J Urol 2002; 168 (4 Pt 1): 1332-6. (1112 men given tadalafil or placebo for 12 weeks, headache in 14% and dyspepsia in 10%, but no “clinically relevant differences in the incidence of abnormal laboratory changes” between placebo and tadalafil). 12352386
Maroy B. [Cytolytic acute hepatitis probably due to sildenafil (Viagra)]. Gastroenterol Clin Biol 2003; 27: 564-5. French. (65 year old man developed malaise within 24 hours of starting sildenafil followed by dark urine [bilirubin not given, ALT 114 times ULN, Alk P 5 times ULN], with rapid recovery; no recurrence on restarting sildenafil suggesting that episode was due to ischemic hepatitis caused by hypotension in the setting of underlying cardiac disease). 12843928
Carson CC. Long-term use of sildenafil. Expert Opin Pharmacother 2003; 4: 397-405. (Review of pharmacology, use, efficacy and safety of sildenafil; currently used by more than 12 million men; no mention of hepatic side effects). 12614192
Michelakis ED, Tymchak W, Noga M, Webster L, Wu XC, Lien D, Wang SH, Modry D, Archer SL. Long-term treatment with oral sildenafil is safe and improves functional capacity and hemodynamics in patients with pulmonary arterial hypertension. Circulation 2003; 108: 2066-9. (Five patients given sildenafil at 50 mg thrice daily for 3 months had improvement in functional capacity and decreases in pulmonary artery pressure: “Liver enzymes … remained unchanged”). 14568893
Masson P, Lambert SM, Brown M, Shabsigh R. PDE-5 inhibitors: current status and future trends. Urol Clin North Am 2005; 32: 511-25. (Review of PDE5 inhibitors including mechanisms of action, pharmacology, efficacy and safety in therapy of erectile dysfunction; no mention of hepatic toxicity or ALT elevations on therapy). 16291042
Balian A, Touati F, Huguenin B, Prevot S, Perlemuter G, Naveau S, Chaput JC. [Probable sildenafil (Viagra) induced acute hepatitis in a patient with no other risk factors]. Gastroenterol Clin Biol 2005; 29: 89. French. (56 year old man developed jaundice 3 weeks after taking 2 doses of sildenafil [bilirubin 8 times ULN, ALT 8 times ULN, Alk P 2 times ULN], resolving 1 month later). 15738907
Daghfous R, El Aidli S, Zaiem A, Loueslati MH, Belkahia C. Sildenafil-associated hepatotoxicity. Am J Gastroenterol 2005; 100: 1895-6. (49 year old man developed right upper quadrant pain 4 weeks after starting sildenafil for erectile dysfunction [bilirubin and Alk P normal, ALT 1.2 times ULN], with rapid resolution with stopping, but not appearing on rechallenge; more likely gastrointestinal intolerance rather than frank hepatotoxicity). 16086731
van Ahlen H, Zumbé J, Stauch K, Landen H. The real-life safety and efficacy of vardenafil: an international post-marketing surveillance study—results from 29,358 German patients. J Int Med Res 2005; 33: 337-48. (Postmarketing use and safety report covering ~30,000 patients; adverse reactions in 1.3%, but no report or mention of liver injury). 15938595
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to a PDE5 inhibitor). 18955056
Wolfhagen FH, Vermeulen HG, de Man RA, Lesterhuis W. Initially obscure hepatotoxicity attributed to sildenafil. Eur J Gastroenterol Hepatol 2008; 20: 710-2. (59 year old man developed jaundice and pruritus after using sildenafil intermittently for 3 months [bilirubin 5.2 rising to 19 mg/dL, ALT 1665 U/L, Alk P 173 U/L], resolving within 3 months of stopping [Sildenafil: Case 1]). 18679077
Enomoto M, Sakaguchi H, Ominami M, Iwai S, Morikawa H, Tamori A, Kawada N. Sildenafil-induced severe cholestatic hepatotoxicity. Am J Gastroenterol 2009; 104: 254-5. (58 year old man developed jaundice and pruritus one month after starting sildenafil [bilirubin 8.5 mg/dL, ALT 64 U/L, Alk P 476 U/L] without rash, fever, eosinophilia or autoantibodies, biospy showing intrahepatic cholestasis, resolved over ensuing 4 months). 19098889
Essaid A, Timraz A. [Cholestatic acute hepatitis induced by tadalafil (Cialis)]. Gastroenterol Clin Biol 2010; 34(4-5): e1-2. French. (38 year old man developed fatigue followed by jaundice 5 days after starting tadalafil [bilirubin 2.5 mg/dL, ALT 4 times ULN, Alk P 4 times ULN], resolving within 2 months of stopping). 20171032
Eriksson C, Gustavsson A, Kronvall T, Tysk C. Hepatotoxicity by bosentan in a patient with portopulmonary hypertension: a case-report and review of the literature. J Gastrointestin Liver Dis 2011; 20: 77-80. (29 year old woman with pulmonary hypertension developed jaundice 18 months after starting long term bosentan [bilirubin 10 mg/dL, ALT 600 U/L, Alk P 480 U/L, INR 1.8], resolving within 8 weeks on prednisone and not recurring when switched to sildenafil and ambrisenatan).21451802
Arif SA, Poon H. Tadalafil: a long-acting phosphodiesterase-5 inhibitor for the treatment of pulmonary arterial hypertension. Clin Ther 2011; 33: 993-1004. (Review of pharmacology, efficacy and safety of tadalafil in pulmonary hypertension states that minor side effects are common, but does not mention hepatotoxicity or ALT levels). 21762988
Jing ZC, Yu ZX, Shen JY, Wu BX, Xu KF, Zhu XY, Pan L, et al.; Efficacy and Safety of Vardenafil in the Treatment of Pulmonary Arterial Hypertension (EVALUATION) Study Group. Vardenafil in pulmonary arterial hypertension: a randomized, double-blind, placebo-controlled study. Am J Respir Crit Care Med 2011; 183: 1723-9. (Controlled trial of vardenafil vs placebo in 66 patients with pulmonary hypertension reported that adverse events were “generally mild and transient”, not mentioning hepatotoxicity or ALT levels). 21471085
Goldstein I, McCullough AR, Jones LA, Hellstrom WJ, Bowden CH, Didonato K, Trask B, Day WW. A randomized, double-blind, placebo-controlled evaluation of the safety and efficacy of avanafil in subjects with erectile dysfunction. J Sex Med 2012; 9: 1122-33. (Controlled trial of 3 doses of avanafil vs placebo for 12 weeks in 646 men with erectile dysfunction; adverse events included headache, flushing, back pain, nasal congestion and bronchitis; no mention of ALT levels or hepatotoxicity). 22248153
Lowe G, Costabile RA. 10-Year analysis of adverse event reports to the Food and Drug Administration for phosphodiesterase type-5 inhibitors. J Sex Med 2012; 9: 265-70. (Among 26,451 spontaneous reports [2,181 deaths] submitted to the FDA over 10 years, adverse events included cardiovascular events, deafness, amnesia, flushing, rash, tinnitus, headahce and excessive masturbation; ALT elevations and liver injury were not mentioned). 22023666
Burke RM, Evans JD. Avanafil for treatment of erectile dysfunction: review of its potential. Vasc Health Risk Manag 2012; 8: 517-23. (Review of pharmacology, mechanism of action, clinical efficacy and safety of avanafil based upon three premarketing studies; discussion of safety makes no mention of blood chemistry results, ALT levels or hepatotoxicity). 22973106
Kedia GT, Uckert S, Assadi-Pour F, Kuczyk MA, Albrecht K. Avanafil for the treatment of erectile dysfunction: initial data and clinical key properties. Ther Adv Urol 2013; 5: 35-41. (Review of the clinical trials of avanafil in erectile dysfunction mentions that severe adverse events were rare, but no specific discussion of side effects or mention of ALT elevations or hepatotoxicity). 23372609
Avanafil (Stendra) - another PDE5 inhibitor for erectile dysfunction. Med Lett Drugs Ther 2014; 56 (1442): 37-8. (Concise review of the mechanism of action, efficacy and safety of avanafil shortly after its approval in the US; no mention of ALT elevations or hepatotoxicity). 24818838
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, Presentation and Outcomes in Patients with Drug-Induced Liver Injury in the General Population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to sildenafil or other PDE5 inhibitors). 23419359
Lasaponara F, Sedigh O, Pasquale G, Bosio A, Rolle L, Ceruti C, Timpano M, et al. Phosphodiesterase type 5 inhibitor treatment for erectile dysfunction in patients with end-stage renal disease receiving dialysis or after renal transplantation. J Sex Med 2013; 10: 2798-814. (Review of published reports on use of PDE5 inhibitors to treat erectile dysfunction in patients on hemodialysis and patients with renal transplants, found similar efficacy and safety as reported in healthy persons; no mention of ALT elevations or hepatotoxicity). 23346948
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, but none were attributed to sildenafil or other PDE5 inhibitors). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to sildenafil or other PDE5 inhibitors). 25754159
Nissan R, Poperno A, Stein GY, Shapira B, Fuchs S, Berkovitz R, Hess Z, et al. A case of hepatotoxicity induced by adulterated "Tiger King", a Chinese herbal medicine containing sildenafil. Curr Drug Saf 2016; 11: 184-8. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/26560492) (65 year old man developed acute liver injury 2 weeks after taking a product for erectile dysfunction called "Tiger King" that was later found to be adulterated with sildenafil [bilirubin 1.8 mg/dL, ALT 984 U/L, Alk P 326 U/L, INR 1.37], recovering within 1 month with supportive care only).
Graziano S, Montana A, Zaami S, Rotolo MC, Minutillo A, Busardò FP, Marinelli E. Sildenafil-associated hepatoxicity: a review of the literature. Eur Rev Med Pharmacol Sci 2017; 21 (1 Suppl): 17-22. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/28379598) (Review of the literature on sildenafil hepatotoxicity with clinical descriptions of the five published cases).

## OTHER REFERENCE LINKS

1. Recent References on PDE5 Inhibitors: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Cyclic+Nucleotide+Phosphodiesterases,+Type+5+%5BMH%5D+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on PDE5 Inhibitors: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=pde5inhibitor)